# Methylphenidate

## OVERVIEW

### Introduction

Methylphenidate is a central nervous system stimulant used for the therapy of attention deficit disorder and narcolepsy. Methylphenidate has been linked to a low rate of serum aminotransferase elevations during therapy and to rare instances of acute, clinically apparent liver injury, generally after its intravenous abuse.

### Background

Methylphenidate (meth" il fen' i date) is a piperidine derivative that is structurally related to amphetamine which acts as a central nervous system (CNS) sympathomimetic stimulant, probably by causing release of norepinephrine at CNS nerve terminals promoting neurotransmission. Methylphenidate may also affect dopaminergic neurotransmission. Therapy with methylphenidate has been shown to increase cognitive abilities and improve psychological functioning and performance in children and adults with suspected attention deficit disorders. It has a paradoxical calming action in children with hyperactivity. Methylphenidate is also used in the therapy of narcolepsy. Methylphenidate was approved for use in the United States for attention deficit disorder in adults in 1955, and its indications were subsequently broadened to include children above the age of 6 and adolescents with attention deficit disorder. Methylphenidate is available in multiple forms for oral administration including capsules, tablets, oral solutions and as extended release and long acting forms in concentrations varying from 2.5 to 54 mg in generic forms and under several brand names including Ritalin, Concerta, Jornay and Quillvant. A transdermal formulation is also available under the brand name Daytrana. The usual initial dose of standard oral methylphenidate in adults is 10 mg two times daily, and average maintenance dosage is 40 to 60 mg daily in 2 or 3 divided doses. The dosage in children varies by formulation. Methylphenidate is a controlled substance (Schedule II) and has abuse potential. Common side effects include headache, insomnia, irritability, palpitations, tachycardia, nasal stuffiness, decreased appetite, nausea, cough and rash. Uncommon, but potentially severe adverse events include psychotic symptoms, cardiovascular events, abuse and dependence and, with long term therapy in children, reduced adult height.

### Hepatotoxicity

In prelicensure clinical trials, methylphenidate was not associated with serum aminotransferase elevations or instances of hepatic injury, but reports of enzyme elevations were received by the sponsor and appeared in publications after it was marketed. The elevations were transient, mild-to-moderate in severity and rarely associated with jaundice or symptoms. In addition, there have been several case reports of marked serum enzyme elevations with jaundice and clinically apparent acute liver injury attributed to methylphenidate given intravenously. These cases occurred largely after illicit intravenous use of methylphenidate and frequently in patients with underlying chronic hepatitis C. The onset was generally soon after initiation of therapy. The pattern of liver enzyme elevations was hepatocellular and the clinical phenotype typical of acute hepatic necrosis with rapid onset and rapid recovery. Immunoallergic features were uncommon. A single case associated with low levels of autoantibodies has been published. Some cases have been severe and at least one fatality after intravenous abuse has been reported. Recurrence upon rechallenge was been documented in one instance (Case 1).

Likelihood score: C[HD] (probable cause of clinically apparent liver injury when given in high doses).

### Mechanism of Injury

The mechanism by which methylphenidate might cause liver injury is unknown, but the injury occurring after intravenous use is likely due to direct toxicity. Methylphenidate is extensively metabolized in the liver and has many drug-drug interactions.

### Outcome and Management

The liver injury due to oral methylphenidate is usually self-limited and resolves rapidity. Injury from intravenous use can be severe and fatalities have been reported. There have been no instances of chronic liver injury or vanishing bile duct syndrome associated with either oral or intravenous methylphenidate. Cross reactivity with other amphetamine related chemicals has not been demonstrated. However, recurrence of injury with reexposure has been demonstrated.

Central nervous system stimulants used for attention deficit disorder, narcolepsy or excessive sleepiness include methylphenidate, atomoxetine, modafinil, armodafinil and the amphetamines. Stimulants that are no longer used for medical conditions, but that are abused, include cocaine and ecstasy or methylenedioxymethamphetamine. Non-stimulants used for attention deficit disorder include the antihypertensive alpha-2 agonists, clonidine and guanfacine.

Drug Class: CNS Stimulants, Attention Deficit Disorder Agents

Other Drugs for Attention Deficit Disorder: Clonidine, Guanfacine

## CASE REPORT

### Case 1. Acute hepatic necrosis after intravenous injection of methylphenidate.(1)

A 19 year old woman who had been abusing methylphenidate developed fatigue, fever and jaundice. She admitted to intravenous injection of methylphenidate tablets that had been dissolved in water. She had no history of liver disease or alcohol abuse. She was not taking other medications. On physical examination, she was jaundiced and had an enlarged, slightly tender liver. There were no peripheral manifestations of cirrhosis or chronic liver disease. Laboratory tests showed elevations in serum bilirubin (13 mg/dL) and AST (4,942 U/L), with minimal increase in alkaline phosphatase (100 U/L) (Table). Tests for hepatitis A and B were negative. Tests for hepatitis C were not available at the time of this report. A liver biopsy showed focal necrosis and portal inflammation with lymphocytes, plasma cells and eosinophils, typical of drug induced liver injury. Rechallenge with 4 injections of 20 mg of methylphenidate over two days led to rapid recurrence with a similar pattern of injury.

#### Key Points

Medication: | Methylphenidate (by injection)
Pattern: | Hepatocellular (R=~100)
Severity: | 3+ (jaundice, hospitalization)
Latency: | Few days
Recovery: | Two weeks
Other medications: | None mentioned

#### Laboratory Values

Days After Stopping | AST* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Comments
| Intravenous abuse of methylphenidate
3 | 4942 | 100 | 13.0 | Admission for jaundice
5 | 2300 | | 14.5
6 | 2090 | | 16.0 | Liver Biopsy
7 | 1900 | | 17.0
9 | 1650 | | 17.2
11 | 900 | | 14.0
14 | 250 | | 11.0
16 | 80 | | 6.0
18 | 25 | | 2.5
| Rechallenge with four injections of 20 mg of methylphenidate
0 | 15 | | 0.5 | Started rechallenge
0 | 450 | | 2.5 | Stopped rechallenge
1 | 900 | | 4.0
2 | 550 | | 5.1
3 | 100 | | 5.2
5 | 50 | | 3.0
7 | 20 | | 1.0 | Normal
Normal | <42 | <115 | <1.2

* Values estimated from Figure 1.

#### Comment

Abuse of methylphenidate and intravenous injections of dissolved tablets led to marked jaundice and serum enzyme elevations. Tests for hepatitis C were not available at the time of the report, but intravenous rechallenge led to recurrence with a similar pattern of injury. This degree of severity of liver injury has not been reported with oral methylphenidate which is a widely used medication with excellent tolerance. The pattern of injury associated with intravenous methylphenidate abuse is similar to that described with amphetamine, methylenedioxymethamphetamine and cocaine use, with acute hepatic necrosis (often with other organ damage) arising within 2 to 4 days of the exposure or overdose. Typical of methylphenidate, cocaine and amphetamine hepatotoxicity from intravenous exposure is both the rapidity of the rise and rapidity of the fall in serum aminotransferase levels. LDH levels can be similarly elevated, while alkaline phosphatase values are usually normal or near normal.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Methylphenidate – Generic, Concerta®, Daytrana®, Jornay PM®, Ritalin®

DRUG CLASS

Central Nervous System Stimulants

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Methylphenidate)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Methylphenidate | 113-45-1 | C14-H19-N-O2

## CITED REFERENCE

1 Mehta H, Murray B, LoIudice TA. Hepatic dysfunction due to intravenous abuse of methylphenidate hydrochloride. J Clin Gastroenterol 1984; 6: 149-51.6715854

## ANNOTATED BIBLIOGRAPHY

References updated: 24 August 2021

Abbreviations: ADHD, attention-deficit/hyperactivity disorder.

Zimmerman HJ. Methylphenidate. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 712. (Expert review of hepatotoxicity published in 1999; methylphenidate has been implicated in at least 3 instances of hepatic injury including two with positive rechallenge).
Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 443-62. (Review of hepatotoxicity of antidepressants mentions that methylphenidate has been implicated in hepatocellular injury).
Westfall TC, Macarthur H, Westfall DP. Methylphenidate. Adrenergic agonists and antagonists. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 191-223. (Textbook of pharmacology and therapeutics).
Goodman CR. Hepatotoxicity due to methylphenidate hydrochloride. N Y State J Med 1972; 72: 2339-40. (67 year old woman with depression developed mild elevations in ALT [56 U/L] and AST [72 U/L] without symptoms or jaundice 2 weeks after starting methylphenidate, and with rapid resolution on stopping and recurrence after 5 day rechallenge [bilirubin 0.6 mg/dL, ALT 145 U/L, AST 535 U/L, Alk P 18 U/L]). 4506888
Mehta H, Murray B, LoIudice TA. Hepatic dysfunction due to intravenous abuse of methylphenidate hydrochloride. J Clin Gastroenterol 1984; 6: 149-51. (19 year old woman developed jaundice soon after starting injecting methylphenidate [bilirubin 13.0 mg/dL, AST 4,942 U/L, Alk P 100 U/L], resolving over next few weeks; upon challenge injection of methylphenidate [20 mg] AST rose to ~900 U/L and bilirubin to 5.2 mg/dL in 3-4 days: Case 1). 6715854
Stecyk O, Loludice TA, Demeter S, Jacobs J. Multiple organ failure resulting from intravenous abuse of methylphenidate hydrochloride. Ann Emerg Med 1985; 14: 597-9. (32 year old woman developed weakness, nausea and dyspnea 2 hours after injecting methylphenidate which she had been doing for ~5 months [bilirubin 1.4 mg/dL, ALT 2,560 U/L, Alk P 174 U/L, lactate 18 mEq/L, arterial pH 7.23, protime 23.7 sec and creatinine 4.0 mg/dL], requiring ICU care, but ultimate recovery over next few weeks). 3994088
Hoover-Stevens S, Kovacevic-Ristanovic R. Management of narcolepsy in pregnancy. Clin Neuropharmacol 2000; 23: 175-81. (Review of the efficacy of medications for narcolepsy and their safety during pregnancy and breast feeding; there have been no studies on the safety of methylphenidate in pregnancy). 11020119
Leonard BE, McCartan D, White J, King DJ. Methylphenidate: a review of its neuropharmacological, neuropsychological and adverse clinical effects. Hum Psychopharmacol 2004; 19: 151-80. (Review of mechanism of action, clinical efficacy and safety of methylphenidate; no mention of hepatotoxicity or serum ALT elevations). 15079851
Lewis JJ, Iezzoni JC, Berg CL. Methylphenidate-induced autoimmune hepatitis. Dig Dis Sci 2007; 52: 594-7. (57 year old man developed marked enzyme elevations 4 years after liver transplantation for hepatitis C and 1 month after starting methylphenidate [bilirubin 2.7 rising to 4.1 mg/dL, ALT 338 U/L, ANA 1:80, IgG 1950 mg/dL], improving upon stopping methylphenidate and falling to baseline on prednisone therapy). 17219064
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 3 cases were attributed to atomoxetine and one to methylphenidate, but none to cocaine or ecstasy). 18955056
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, 2 agents used for attention deficit disorder were among the top 40 causes; methylphenidate [11th, 96 cases] and atomoxetine [14th, 64 cases]). 21039766
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (Among 313 cases of drug induced liver injury seen between 1997 and 2008 at a large hospital in Bangalore, India, one case was attributed to atomoxetine, none to methylphenidate). 20648003
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including one attributed to cocaine and one to ecstasy but none to methylphenidate). 20949552
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N: Drug-induced Liver Injury Network. Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN prospective study. J Pediatr Gastroenterol Nutr 2011; 53: 182-9. (Among 30 children with suspected drug induced liver injury, 3 were attributed to atomoxetine and one to methylphenidate). 21788760
Cantrell FL, Ogera P, Mallett P, McIntyre IM. Fatal oral methylphenidate intoxication with postmortem concentrations. J Forensic Sci 2014; 59: 847-9. (62 year old woman with chronic hepatitis C was found dead at home and autopsy showed high levels of methylphenidate consistent with drug overdose; liver histology showed chronic hepatitis and mild fatty change and no evidence of acute liver injury). 24502813
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to methylphenidate). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none of which were attributed methylphenidate). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 [1.3%] were attributed to drugs used in transplant rejection, including 10 to azathioprine and 1 to tacrolimus, but none to mycophenolate). 25754159
Newcorn JH, Nagy P, Childress AC, Frick G, Yan B, Pliszka S. Randomized, double-blind, placebo-controlled acute comparator trials of lisdexamfetamine and extended-release methylphenidate in adolescents with attention-deficit/hyperactivity disorder. CNS Drugs 2017; 31: 999-1014. (Among 1013 adolescents with attention deficit/hyperactivity disorder treated with methylphenidate or lisdexamfetamine or placebo for 6 or 8 weeks, both drugs improved symptoms more than placebo but both had higher and similar rates of adverse events; no mention of ALT elevations or hepatoxicity or discontinuations for hepatic adverse events). 28980198
Edvinsson D, Ekselius L. Long-term tolerability and safety of pharmacological treatment of adult attention-deficit/hyperactivity disorder: a 6-year prospective naturalistic study. J Clin Psychopharmacol 2018; 38: 370-5. (Among 112 adults with attention deficit disorder started on methylphenidate and followed for up to 6 years, half had discontinued treatment but no mention is made of ALT elevations, hepatotoxicity or drug discontinuations because of hepatic adverse events). 29927781
Cortese S, Adamo N, Mohr-Jensen C, Hayes AJ, Bhatti S, Carucci S, Del Giovane C, et al.; European ADHD Guidelines Group (EAGG). Comparative efficacy and tolerability of pharmacological interventions for attention-deficit/hyperactivity disorder in children, adolescents and adults: protocol for a systematic review and network meta-analysis. BMJ Open 2017; 7(1): e013967. (Review of the pharmacological therapy of ADHD with discussion of amphetamines, methylphenidate, atomoxetine, guanfacine and clonidine; no mention of ALT elevations during therapy or hepatotoxicity).
Fekete S, Romanos M, Gerlach M. [Does methylphenidate cause liver damage? An analysis of ad hoc reports to the "Bundesinstitut für Arzneimittel und Medizinprodukte (BfArM)"]. Z Kinder Jugendpsychiatr Psychother 2018; 46: 342-8. German. (Analysis of cases of suspected methylphenidate liver injury reported to the German Federal Institute for Drugs and Medical Devices between 2006 and 2016 identified 60 cases, but most were unlikely or incomplete, only 11 were considered possible and 9 probable, most marked by serum enzyme elevations without jaundice but one with acute liver failure). 29237323
Schoretsanitis G, de Leon J, Eap CB, Kane JM, Paulzen M. Clinically significant drug-drug interactions with agents for attention-deficit/hyperactivity disorder. CNS Drugs. 2019; 33: 1201-22. (Review of drug-drug interactions of agents used to treat ADHD mentions that there is little information on the metabolism of clonidine and possible drug-drug interactions). 31776871
Joshi G, DiSalvo M, Wozniak J, Ceranoglu TA, Yule A, Surman C, Fried R, et al. A prospective open-label trial of long-acting liquid methylphenidate for the treatment of attention deficit/hyperactivity disorder in intellectually capable adults with autism spectrum disorder. World J Biol Psychiatry 2020; 21(4): 274-90. (Among 15 adults with attention deficit disorder treated with long acting methylphenidate, adverse events were frequent including headache [53%], insomnia [33%], anxiety [33%], and decreased appetite [27%]; no mention of ALT elevations or hepatotoxicity). 31607204
Drugs for ADHD. Med Lett Drugs Ther 2020; 62(1590): 9-15. (Concise review of drugs for attention deficit/hyperactivity disorder mentions that methylphenidate and the CNS stimulants are the first line agents for school age children and adolescents and that adverse events can include decreased appetite, abdominal pain, headache and insomnia, but does not mention ALT elevations or hepatotoxicity). 31999670
Kis B, Lücke C, Abdel-Hamid M, Heßmann P, Graf E, Berger M, Matthies S, et al. Safety profile of methylphenidate under long-term treatment in adult ADHD patients – results of the COMPAS Study. Pharmacopsychiatry 2020; 53: 263-71. (Among 433 adults with ADHD treated with methylphenidate or placebo combined with cognitive behavioral group psychotherapy, adverse events that were common with methylphenidate included decrease in appetite [22% vs 4%], dry mouth [15% vs 5%], palpitations [11% vs 3%], agitation [11% vs 3%], restlessness [6% vs 2%], sweating and tachycardia, while liver enzyme elevations were rare [0.5% vs none]). 33017854
Weiss MD, Childress AC, Donnelly GAE. Efficacy and safety of PRC-063, extended-release multilayer methylphenidate in adults with ADHD including 6-month open-label extension. J Atten Disord 2021: 25(10): 1417-28. (Among 375 adults with attention deficit/hyperactivity disorder treated with 1 of 4 doses of extended release methylphenidate or placebo once daily for 6 months, adverse events included headache, insomnia, decreased appetite, dry mouth, and nausea, and there were “no clinically significant changes from baseline in laboratory findings”). 31916473
Huang YS, Yeh CB, Chen CH, Shang CY, Gau SS. A randomized, double-blind, placebo-controlled, two-way crossover clinical trial of ORADUR-methylphenidate for treating children and adolescents with attention-deficit/hyperactivity disorder. J Child Adolesc Psychopharmacol 2021; 31: 164-78. (Among 100 children and adolescents with ADHD treated in a 2 week cross over study of extended release methylphenidate vs placebo, ADHD symptoms improved with methylphenidate and “there were no significant changes in laboratory safety profiles”). 33395356
Childress A, Cutler AJ, Marraffino AH, Bhaskar S, Donnelly G. Randomized, double-blind, placebo-controlled, parallel-group, adult laboratory classroom study of the efficacy and safety of PRC-063 (extended-release methylphenidate) for the treatment of ADHD. J Atten Disord. 2022;26(6):857-869. (Among 288 adults with ADHD treated with once daily extended release methylphenidate with dose optimization over 7 weeks, classroom performance improved with therapy and adverse events included headache, decreased appetite, and insomnia but “there were no clinically meaningful changes in mean values for clinical chemistry” results). 34189995

## OTHER REFERENCE LINKS

Recent References on Methylphenidate: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=methylphenidate+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Methylphenidate: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=methylphenidate)